# Ketorolac

## OVERVIEW

### Introduction

Ketorolac is a potent, short acting nonsteroidal antiinflammatory drug (NSAID) that is available in both parenteral and oral forms that is used to treat severe pain but for no more than five days. Ketorolac has been linked to few, poorly understood instances of clinically apparent liver injury in the published literature.

### Background

Ketorolac tromethamine belongs to the acetic acid class of NSAIDs similar to diclofenac and etodolac. Like other NSAIDs, ketorolac is a potent cyclo-oxygenase (Cox) inhibitor which blocks the formation of proinflammatory prostaglandins that are important in pain and inflammatory pathways. Ketorolac was approved in the United States in 1991 and current indications are limited to the short term management of moderately severe, acute pain. Ketorolac is available in parenteral and oral forms in multiple generic forms and under the brand name Toradol. The recommended dose is 60 mg intramuscularly or 30 mg intravenously initially, followed by 30 mg every 6 hours for up to 5 days. An oral form is available in 10 mg tablets for switching from the parenteral form and is given every 6 to 8 hours, but continuation beyond 5 days is not recommended. More prolonged therapy is associated with a high risk for nephrotoxicity and other complications. Ketorolac is available by prescription only and it is used largely for management of postoperative pain. Common side effects include gastrointestinal upset, nausea, headache and itching. As with other NSAIDS, ketorolac has several potential serious adverse effects, including severe gastrointestinal complications [such as ulcers, bleeding, or perforation], increase risk of cardiovascular thrombotic events [such as myocardial infarction or stoke], renal dysfunction, heart failure and edema, exacerbation of asthma, infertility, fetal toxicity and hypersensitivity reactions.

### Hepatotoxicity

Prospective studies show that up to 1% of patients taking ketorolac experience at least transient serum aminotransferase elevations. These may resolve even with drug continuation. Marked aminotransferase elevations above 3 times the upper limit of normal (ULN) occur in less than 1% of patients. Clinically apparent liver injury with jaundice from ketorolac has not been described in any detail so that the latency, clinical features and prognosis of injury is unknown. Ketorolac is not mentioned as an etiologic agent in large case series on drug induced liver injury or acute liver failure from the United States. However, the antiplatelet activity of ketorolac can lead to complications mostly due to platelet dysfunction and bleeding, and several instances of hepatic rupture and subcapsular hepatic hematomas have been reported with its use which might present clinically as acute liver injury.

Likelihood score: D (possible rare cause of clinically apparent liver injury, perhaps due to bleeding episodes).

### Mechanism of Injury

The mechanism of ketorolac hepatotoxicity, if it exists, is not known. The hepatic hematomas described after its use are probably caused by the antiplatelet activity of ketorolac given in the perioperative period.

### Outcome and Management

Only asymptomatic elevations in serum aminotransferase levels have been reported associated with ketorolac therapy. The drug is rarely used outside of hospitals and it is recommended that it be used for no more than 5 days, perhaps accounting for the rarity or absence of hepatic injury.

Drug Class: Nonsteroidal Antiinflammatory Drugs

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ketorolac – Generic, Toradol®

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ketorolac)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ketorolac | 74103-06-3 | C15-H13-N-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 05 August 2025

Abbreviations used; NSAIDS, nonsteroidal antiinflammatory drugs.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. The NSAIDS. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-41. (Review of hepatotoxicity of NSAIDs published in 1999; ketorolac is not mentioned).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. pp. 370-402. (Review of hepatotoxicity of NSAIDs mentions that ketorolac has not been implicated in cases of clinically apparent liver injury in the published literature).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. pp. 685-709. (Textbook of pharmacology and therapeutics).
Brocks DR, Jamali F. Clinical pharmacokinetics of ketorolac tromethamine. Clin Pharmacokinet 1992; 23: 415-27. (Ketorolac is produced as a tromethamine salt to allow water solubility and parenteral administration, is rapidly absorbed, has a half life of 4-6 hours, is highly protein bound, extensively conjugated in the liver and excreted in urine). 1458761
Erstad BL, Rappaport WD. Subcapsular hematoma after laparoscopic cholecystectomy, associated with ketorolac administration. Pharmacotherapy 1994; 14: 613-5. (35 year old woman developed subcapsular hepatic hematoma 10 hours after receiving intravenous ketorolac after laparoscopic cholecystectomy). 7997396
Hennessy S, Kinman JL, Berlin JA, Feldman HI, Carson JL, Kimmel SE, et al. Lack of hepatotoxic effects of parenteral ketorolac in the hospital setting. Arch Intern Med 1997; 157: 2510-4. (Analysis of safety based upon 10,272 courses of ketorolac given to 9900 patients in 35 hospitals, average duration of therapy was for 2.6 days [range 1-44]; ALT elevations above 3 times the upper limit of normal occurred in 0.7% of ketorolac vs 0.9% of opioid courses). 9385304
Zimmerman HJ. Update of hepatotoxicity due to classes of drugs in common clinical use: non-steroid drugs, anti-inflammatory drugs, antibiotics, antihypertensives, and cardiac and psychotropic agents. Semin Liver Dis 1990; 10: 322-8. (Extensive review article on liver injury due to NSAIDs; ketorolac is not discussed). 2281340
Vuilleumier H, Halkic N. Ruptured subcapsular hematoma after laparoscopic cholecystectomy attributed to ketorolac-induced coagulopathy. Surg Endosc 2003; 17: 659. (23 year old woman received ketorolac after routine laparoscopic cholecystectomy and presented 18 hours later with subcapsular hematoma of the liver attributed to platelet effects of ketorolac). 12574932
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of drug induced liver injury with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; among 103 cases, 3 attributed to naproxen, but none to ketorolac). 16165719
Lapeyre-Mestre M, de Castro AM, Bareille MP, Del Pozo JG, Requejo AA, Arias LM, et al. Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol 2006; 20:391-5. (Analysis of reports of liver injury from NSAIDs from France and Spain from 1982-2001; among more than 29,000 liver adverse event reports, 11 were for ketorolac; no clinical details given; ketorolac withdrawn from France in 1994 because of gastrointestinal side effects). 16867024
Guercio G, Sandonato L, Cintorino D, Ricotta C, Diana G. [Hemoperitoneum from rupture of liver subcapsular hematoma after laparoscopic cholecystectomy attributed to ketorolac. Report of a case]. G Chir 2008; 29: 351-3. Italian. PMID: 18834567 (39 year old woman undergoing laparoscopic cholecystectomy received intravenous ketorolac postoperatively and developed a subcapsular hepatic hematoma 7 hours later).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam and 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen]; none were attributed to ketorolac). 18955056
Minaya Bravo AM, González González E, Ortíz Aguilar M, Larrañaga Barrera E. Two rare cases of intrahepatic subcapsular hematoma after laparoscopic cholecystectomy. Indian J Surg 2010; 72: 481-4. (Two women, ages 29 and 69 years, developed symptomatic subcapsular hepatic hematomas 1 and 5 days after laparoscopic cholecystectomy while receiving intravenous ketorolac for pain; both required surgery and recovered uneventfully). 22131659
Bessone F. Non-steroidal anti-inflammatory drugs: What is the actual risk of liver damage? World J Gastroenterol 2010; 16: 5651-61. (Review of estimated frequency of drug induced liver injury due to NSAIDs from large published epidemiological studies; ketorolac is not discussed). 21128314
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 7 were attributed to NSAIDs including 4 to bromfenac, 2 diclofenac and 1 etodolac, but none to ketorolac). 20949552
Gulmez SE, Larrey D, Pageaux GP, Lignot S, Lassalle R, Jové J, Gatta A, et al. Transplantation for acute liver failure in patients exposed to NSAIDs or paracetamol (acetaminophen): the multinational case-population SALT study. Drug Saf 2013; 36: 135-44. (Among 600 patients undergoing liver transplantation for acute liver failure at 52 European liver transplant centers between 2005 and 2007, 301 were considered idiopathic and had received a medication within 30 days of onset, including acetaminophen in 192 and NSAIDs in 40, including ketorolac in 2 for a rate of 19.5 per million-treatment years). 23325533
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 6 attributed to diclofenac [ranking 2nd], but none to ketorolac or other NSAIDs). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common class of implicated agents being NSAIDS [n=62, 32%], specific agents being nimesulide [n=53], piroxicam [5], diclofenac [2], gold salts [1], and naproxen [1]; ketorolac was not listed]). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 were attributed to NSAIDs, but none to ketorolac [Schmeltzer 2016]). 25754159
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9. (Among 1221 cases of drug induced liver injury enrolled in a prospective, US database between 2004 and 2014, 30 cases [2.5%] were attributed to NSAIDs, most commonly diclofenac; none were attributed to ketorolac). 26601797
Donati M, Conforti A, Lenti MC, Capuano A, Bortolami O, Motola D, Moretti U, et al; DILI-IT Study Group. Risk of acute and serious liver injury associated to nimesulide and other NSAIDs: data from drug-induced liver injury case-control study in Italy. Br J Clin Pharmacol 2016; 82: 238-48. (Among 179 cases of acute liver injury and 1770 controls admitted to 9 Italian hospitals between 2010 and 2014, NSAIDs used more frequently in cases compared to controls included nimesulide [17% vs 10%: odds ratio 1.88] and ibuprofen [14% vs 10%: odds ratio 1.59] and risk was higher in those taking higher doses; ketorolac was not mentioned). 26991794
Zoubek ME, González-Jimenez A, Medina-Cáliz I, Robles-Díaz M, Hernandez N, Romero-Gómez M, Bessone F, et al. High Prevalence of ibuprofen drug-induced Liver injury in Spanish and Latin-American registries. Clin Gastroenterol Hepatol 2018; 16: 292-4. (Analysis of a Spanish and Latin-American registries identified 73 cases of NSAID induced liver injury, the most common agents being nimesulide [38%], diclofenac [34%] and ibuprofen [17%]; ketorolac was not mentioned). 28782674
Maslin B, Lipana L, Roth B, Kodumudi G, Vadivelu N. Safety considerations in the use of ketorolac for postoperative pain. Curr Drug Saf 2017; 12: 67-73. PubMed Citation (Review of the safety of ketorolac in the perioperative period focusing upon renal dysfunction and bleeding; no discussion of ALT elevations or hepatotoxicity). 27440142
Tujios SR, Lee WM. Acute liver failure induced by idiosyncratic reaction to drugs: challenges in diagnosis and therapy. Liver Int 2018; 38: 6-14. (Review of acute liver failure and the contribution of drug induced liver injury, of which 5% were due to NSAIDs, most commonly diclofenac and etodolac; no mention of ketorolac). 28771932
Meunier L, Larrey D. Recent advances in hepatotoxicity of non-steroidal anti-inflammatory drugs. Ann Hepatol 2018; 17: 187-91. (Review of the hepatotoxicity of NSAIDS mentions the most commonly implicated are diclofenac, nimesulide, sulindac, ibuprofen, piroxicam, naproxen and aspirin and that rare instances of idiosyncratic acute hepatitis attributed to celecoxib have been described; no mention of ketorolac). 29469052
Sriuttha P, Sirichanchuen B, Permsuwan U. Hepatotoxicity of nonsteroidal anti-inflammatory drugs: a systematic review of randomized controlled trials. Int J Hepatol. 2018;2018:5253623. . (Systematic review of randomized controlled trials of NSAIDs that reported monitoring for hepatoxicity identified 18 studies but only 3 NSAIDs showed an increase rates of liver injury with the drug compared to placebo, including diclofenac, celecoxib, and etoricoxib; no mention of ketorolac). 29568654
Chen J, Salerno D, Breslin N, Chowdhury T, Lobritto S, Martinez M, Goldner D, et al. Concomitant tacrolimus and ketorolac therapy in pediatric liver transplant recipients: Teaching old dogma new tricks. Clin Transplant. 2021;35:e14141. (Among 84 children undergoing liver transplantation between 2015 and 2019 at a single New York referral center who were treated with tacrolimus, 62 received ketorolac for post-operative pain management for up to 5 days and 22 received other non-NSAID analgesics but serum creatinine, platelet counts, and bleeding episodes were similar between the two groups despite the concern that the two drugs would have additive nephrotoxicity). 33145821
Nonopioid drugs for pain. Med Lett Drugs Ther. 2022;64(1645):33-40. (Concise review of the nonopioid drugs for pain mentions that NSAIDs are considered to be more effective than acetaminophen for mild to moderate pain and that they can cause small increases in serum aminotransferase levels but that serious hepatotoxicity is rare; mentions that ketorolac is available as tablets, a solution for injection, and nasal spray, but its adverse effects are not discussed). 35231019
Pinto VM, Gianesin B, Sardo S, Mazzi F, Baiardi G, Menotti S, Piras F, et al. Safety and efficacy of ketorolac continuous infusion for multimodal analgesia of vaso-occlusive crisis in patients with sickle cell disease. Orphanet J Rare Dis. 2024;19:22. (Among 31 patients treated with ketorolac for up to 72 hours during a total of 48 episodes of sickle cell crisis, pain control was excellent and there was no evidence of excess renal dysfunction, AST elevations, or episodes of bleeding). 38254184
Bonkovsky HL, Ghabril M, Nicoletti P, Dellinger A, Fontana RJ, Barnhart H, Gu J, et al; US DILIN Investigators. Drug-induced liver injury (DILI) ascribed to non-steroidal anti-inflammatory drugs (NSAIDs) in the USA-update with genetic correlations. Liver Int. 2024;44:1409-1421. (Among 55 cases of drug induced liver injury attributed to NSAIDs enrolled in a U.S. database between 2004 and 2022, 29 were attributed to diclofenac, 7 to celecoxib, 5 to ibuprofen, 4 to etodolac and meloxicam, 2 to oxaprozin, and 1 to naproxen and sulindac, but none to ketorolac). 38451034
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be attributed to prescribed medications, at rates for NSAIDs of 1:7,700 for sulindac, 1:8,300 for indomethacin, 1:9,100 for naproxen, 1:11,000 for ibuprofen, 1:12,500 for diclofenac, and 1:14,300 for celecoxib; ketorolac was not mentioned). 38913369
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver injury caused by prescription drugs. Drug Saf. 2025;48:151-160. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study estimated incidence rates of 1 per 4,800 new persons treated each year with diclofenac, 1:25,000 for celecoxib, and 1 per 87,000 for meloxicam, but because no cases were attributed to ketorolac, incidence rates could not be estimated). 39317916
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 458 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, 49 were attributed to NSAIDs, including 19 [4.1%] to diclofenac, 14 [3.0%] to nimesulide and 11 [2.4%] to ibuprofen and 1 case each to celecoxib, ketoprofen, ketorolac, meloxicam, and piroxicam [personal communication]). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Ketorolac: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(ketorolac/AE+NOT+clavulanic+acid)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Ketorolac: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=ketorolac)